# Donanemab

## OVERVIEW

### Introduction

Donanemab is a humanized monoclonal antibody to aggregated amyloid β which has been approved for use in Alzheimer disease with mild cognitive impairment or mild dementia. Donanemab is associated with a minimal rate of serum aminotransferase elevations during therapy and has not been linked to instances of clinically apparent liver injury.

### Background

Donanemab (doe nan’ e mab) is a humanized monoclonal IgG1 antibody directed against insoluble N-truncated pyroglutamate amyloid β which was developed as therapy for Alzheimer disease, based upon the theory that the dementia and neurological decline in Alzheimer disease is caused by accumulation of amyloid β oligomers and fibrils in the frontal lobes of the brain. Studies in animal models and in humans demonstrated that the monoclonal antibody causes a decrease in amyloid β plaque accumulation as shown by advanced imaging techniques. Donanemab was evaluated in large, randomized double-blind controlled trials in more than 1700 patients with symptomatic, early stages of Alzheimer disease and evidence of amyloid β plaques accumulation. Therapy was associated with a statistically significant but modest decrease in the rate of decline in dementia rating scales, but did not stop the decline or reverse the cognitive impairment. Analysis of subgroups indicated that donanemab was most effective in slowing decline in patients with lesser amounts of amyloid plaques at baseline. In 2024, donanemab was approved as therapy of patients with Alzheimer disease with mild cognitive impairment or mild dementia and documented amyloid plaque pathology by imaging. Donanemab is available in single dose vials of 350 mg in 20 mL (17.5 mg/mL) under the brand name Kisunla. The recommended dose is 700 mg administered intravenously (over 30 minutes) every 4 weeks for 3 doses, followed by 1400 mg every 4 weeks with regularly scheduled evaluations for efficacy and safety. Therapy can be discontinued if imagining indicates minimal or no amyloid plaques remaining. Common side effects include infusion reactions, headache, falls, and amyloid related imaging abnormalities such as edema, hemorrhage, and hemosiderin deposition. Uncommon, potentially severe adverse reactions include hypersensitivity reactions.

### Hepatotoxicity

Serum aminotransferase elevations were infrequent in the controlled trials of donanemab in Alzheimer disease and no more frequent than with placebo treatment. The elevations were transient, asymptomatic, and mild-to-moderate in severity (1 to 3 times upper limit of normal). In the preregistration trials there were no instances of clinically apparent liver injury or severe hepatic adverse events attributed to donanemab. Clinical use outside of randomized controlled trials has been limited.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms by which donanemab might cause liver injury are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of amyloid β accumulation or increase in its clearance would trigger liver injury or autoimmune liver conditions.

Drug Class: Monoclonal Antibodies, Alzheimer Disease Agents

Other Alzheimer Monoclonal Antibodies: Aducanumab, Lecanemab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Donanemab – Kisunla®

DRUG CLASS

Alzheimer Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Donanemab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Donanemab | 1931944-80-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 04 October 2024

Abbreviations used: iv, intravenously.

Roberson ED. Alzheimer Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 333-5. (Textbook of pharmacology and therapeutics).
FDA. Clinical Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/761248Orig1s000MedR.pdf (Multidisciplinary FDA review of data on the safety and efficacy of donanemab in support of its approval for use in Alzheimer disease in the US, mentions that in prelicensure studies there were no “clinically meaningful changes in laboratory values,” no differences in rates of ALT elevation between donanemab- vs placebo-treated patients [0.4% vs 0.3%], and no instances of clinically apparent liver injury).
Selkoe DJ, Hardy J. The amyloid hypothesis of Alzheimer's disease at 25 years. EMBO Mol Med 2016; 8: 595-608. (Analysis of the role of amyloid-β in the etiology of Alzheimer disease supported by findings that the dominant mutations in amyloid precursor protein [APP] or the protease that metabolizes presenilin and generates amyloid-β are associated with early onset dementia, suggesting that imbalance of generation and clearance of amyloid-β is the early and perhaps initiating factor in Alzheimer disease, and that monoclonal antibody therapy by increasing clearance might help correct the dyshomeostasis). 27025652
Sevigny J, Chiao P, Bussière T, Weinreb PH, Williams L, Maier M, Dunstan R, et al. The antibody aducanumab reduces Aβ plaques in Alzheimer's disease. Nature 2016; 537: 50-6. (Among 165 patients with early Alzheimer disease treated with 1 of 4 doses of aducanumab [1, 3, 6, or 10 mg/kg] or placebo monthly for one year, those treated with the higher doses showed evidence of decrease in brain amyloid-β accumulation and a trend for clinical improvement, but also higher rates of vasogenic edema [37% to 40%] compared with placebo [5%]; ALT elevations arose in 4 of 125 [3.2%] on aducanumab vs none of 40 on placebo). 27582220
Alexander GC, Emerson S, Kesselheim AS. Evaluation of aducanumab for Alzheimer disease: scientific evidence and regulatory review involving efficacy, safety, and futility. JAMA 2021; 325: 1717-8. (Summary of the conclusions of the FDA advisory committee on aducanumab which were based upon results of two phase III randomized controlled trials in early Alzheimer disease patients, both of which were terminated early after interim analyses indicated futility; but on post-hoc reanalysis, statistically significant benefit was found with the higher dose in one of the 2 trials; because of discrepancies in outcomes in the two trials and only slight clinical benefit achieved in one arm of the 2 studies, the committee recommended that aducanumab not be approved until another trial confirms the efficacy and safety of the high dose regimen). 33783469
Lowe SL, Duggan Evans C, Shcherbinin S, Cheng YJ, Willis BA, Gueorguieva I, Lo AC, et al. Donanemab (LY3002813) phase 1b study in Alzheimer's disease: rapid and sustained reduction of brain amyloid measured by florbetapir F18 imaging. J Prev Alzheimers Dis. 2021;8:414-424. (Among 61 patients with Alzheimer disease enrolled in a placebo controlled phase 1 study of single and multiple doses of 10 to 40 mg/kg of intravenous donanemab in single or multiple doses, there was rapid decrease in brain amyloid as detected by PET scanning, and adverse events included infusion reactions, vasogenic cerebral edema, cerebral microhemorrhages, and headaches, but “there were no clinically significant changes in …safety laboratories”). 34585215
Lowe SL, Willis BA, Hawdon A, Natanegara F, Chua L, Foster J, Shcherbinin S, et al. Donanemab (LY3002813) dose-escalation study in Alzheimer's disease. Alzheimers Dement (N Y). 2021;7:e12112. (In a dose escalation study of single followed by multiple doses of donanemab, infusion reactions occurred in 16% of patients with Alzheimer disease but “there were no significant findings on clinical labs”). 33614890
Mintun MA, Lo AC, Duggan Evans C, Wessels AM, Ardayfio PA, Andersen SW, Shcherbinin S, et al. Donanemab in early Alzheimer's disease. N Engl J Med. 2021;384:1691-1704. (Among 257 patients with early symptomatic Alzheimer disease treated with iv donanemab or placebo every 4 weeks for 72 weeks, the decrease in amyloid plaque levels was greater and decline in disease rating scales less with the monoclonal antibody, while adverse event rates were similar in the two groups except for infusion reactions and amyloid-related imaging abnormalities of edema and microhemorrhage; no mention of ALT elevations or hepatotoxicity). 33720637
Sims JR, Zimmer JA, Evans CD, Lu M, Ardayfio P, Sparks J, Wessels AM, et al.; TRAILBLAZER-ALZ 2 Investigators. Donanemab in early symptomatic Alzheimer disease: The TRAILBLAZER-ALZ 2 Randomized Clinical Trial. JAMA. 2023;330:512-527. (Among 1736 patients with early symptomatic Alzheimer disease treated with donanemab or placebo iv every 4 weeks for up to 72 weeks, therapy was associated with a slowing but not reversal or prevention of decline in clinical dementia rating scores, and with complications of infusion reactions and brain edema and microhemorrhages; no mention of ALT elevations or hepatotoxicity). 37459141
Donanemab (Kisunla) for Alzheimer's disease. Med Lett Drugs Ther. 2024;66:129-131. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of donanemab shortly after its approval in the US as therapy of Alzheimer disease with mild cognitive impairment or mild dementia, mentions side effects of symptomatic brain amyloid related edema and microhemorrhages, infusion reactions and headache; no mention of ALT elevations or hepatotoxicity). 39137173
Kang C. Donanemab: first approval. Drugs. 2024 Sep 6. . In Press.10.1007/s40265-024-02103-7 (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of donanemab shortly after its approval for use in mildly symptomatic Alzheimer disease in the US, does not mention or discuss ALT elevations or hepatotoxicity). 39404937

## OTHER REFERENCE LINKS

1. Recent References on Donanemab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Donanemab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Donanemab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Donanemab)